# Encorafenib

## OVERVIEW

### Introduction

Encorafenib is a selective inhibitor of BRAF kinase that is used in combination with binimetinib, an inhibitor of MEK, in the therapy of metastatic and advanced malignant melanoma. Encorafenib-binimetinib combination therapy is commonly associated with transient elevations in serum aminotransferase levels during therapy, but has yet to be linked to instances of clinically apparent acute liver injury.

### Background

Encorafenib (en' co raf" e nib) is an orally available, inhibitor of mutated forms of BRAF, a serine/threonine kinase that is a component of the mitogen-activated pathway (MAP) kinases, which are important intracellular signals involved in control of cell growth and proliferation. BRAF is an early step in the cascade of MAP kinases (RAS-RAF-MEK-ERK) and is frequently mutated in malignant conditions, including at least half of cases of melanoma. Binimetinib (bin' i me' ti nib) is an orally available inhibitor of MEK, mitogen-activated protein kinase kinase, another important component of the MAP kinase pathway. Encorafenib was shown to have enhanced activity against selected mutants of BRAF in vitro and in animal models. In clinical trials, the combination of encorafenib with binimetinib was associated with an improvement in overall survival in patients with metastatic malignant melanoma with V600E and V600K mutations in comparison to standard therapies. Furthermore, the combination appeared to be better tolerated than encorafenib alone. The combination of encorafenib with binimetinib was approved for use in the United States in 2018 and current indications are for unresectable or metastatic melanoma with the BRAF V600E or V600K mutations. Encorafenib is available in tablets of 50 and 75 mg under the brand name Braftovi and binimetinib as tablets of 15 mg under the brand name Mektovi. The recommended dose regimen is 450 mg of encorafenib once daily in combination with 45 mg of binimetinib twice daily (30 mg twice daily in patients with moderate or severe liver impairment). The combination should be continued until disease progression or unacceptable toxicities arise. Common side effects include fatigue, nausea, arthralgias, rash, alopecia, photosensitivity, pruritus, and skin papilloma. Uncommon but potentially severe side effects include new primary malignancies, both cutaneous and non-cutaneous, hemorrhage, uveitis and other ocular toxicities, rhabdomyolysis, prolongation of QTc intervals and embryo-fetal toxicity.

### Hepatotoxicity

In large clinical trials of the combination of encorafenib and binimetinib, abnormalities in routine liver tests were common and serum ALT elevations occurred in 26% of patients. ALT and AST values greater than 5 times the upper limit of normal (ULN) occurred in 6% and led to dose modification or discontinuation in 3.6% of patients. However, the aminotransferase abnormalities were generally transient and asymptomatic and there were no reports of clinically apparent liver injury with jaundice reported from the prelicensure studies. Since its approval and more widespread use, there have been no published instances of clinically apparent hepatotoxicity attributed to this combination therapy, but the total experience with its use has been limited.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of injury accounting for serum enzyme elevations during encorafenib/binimetinib therapy is not known. Encorafenib is metabolized in the liver largely through the CYP 3A4 pathway and is susceptible to drug-drug interactions with agents that inhibit or induce hepatic CYP 3A4 activity. Binimetinib is metabolized largely via UGT1A1 and to a lesser extent by CYP 1A2 and 2C19. The two kinase inhibitors do not appear to affect the metabolic disposition of each other. Discontinuation of binimetinib should lead to a reduction in the dose of encorafenib (to 300 mg daily), while discontinuation of encorafenib should trigger discontinuation of binimetinib.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation. There does not appear to be cross reactivity in risk for hepatic injury between encorafenib and binimetinib and other similar kinase inhibitors such as darafenib and vermurafenib and, in some situations, switching to another BRAF/MEK inhibitors may be appropriate.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Encorafenib – Braftovi®

Binimetinib – Mektovi®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Encorafenib%20and%20Binimetinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Encorafenib | 1269440-17-6 | C22-H27-Cl-F-N7-O4-S | Encorafenib and Binimetinib chemical structure
Binimetinib | 606143-89-9 | C17-H15-Br-F2-N4-O3 | Binimetinib chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 15 April 2019

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors such as vemurafenib, encorafenib or binimetinib).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not encorafenib or binimetinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2018/210496Orig1s000MultidisciplineR.pdf (FDA Clinical Review of safety and efficacy of encorafenib and binimetinib).
Flaherty KT, Puzanov I, Kim KB, Ribas A, McArthur GA, Sosman JA, O'Dwyer PJ, et al. Inhibition of mutated, activated BRAF in metastatic melanoma. N Engl J Med 2010; 363: 809-19. (Among 87 patients with metastatic melanoma treated with escalating doses of vemurafenib, objective responses occurred at doses at or above 240 mg twice daily in patients with the BRAF V600E mutation and adverse events included squamous cell carcinoma [21%], arthralgias, rash, nausea, photosensitivity and fatigue; no mention of ALT elevations or hepatotoxicity). 20818844
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; aminotransferase elevations occurred in 35-38% of patients in registration trials of vemurafenib, were above 5 times ULN in 3% and cases of clinically apparent liver injury, but not hepatic failure, have been reported). 23620168
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib). 23556451
Dummer R, Ascierto PA, Gogas HJ, Arance A, Mandala M, Liszkay G, Garbe C, et al. Encorafenib plus binimetinib versus vemurafenib or encorafenib in patients with BRAF-mutant melanoma (COLUMBUS): a multicentre, open-label, randomised phase 3 trial. Lancet Oncol 2018; 19: 603-15. (Preliminary report on a controlled trial comparing the combination of encorafenib and binimetinib with encorafenib alone and vermurafenib alone in patients with advanced or metastatic melanoma, mentions that progression free survival was greatest with the combination, and elevations in serum ALT or AST arose in 7% on the combination vs 2% on monotherapy, but there were no serious hepatic adverse events). 29573941
Dummer R, Ascierto PA, Gogas HJ, Arance A, Mandala M, Liszkay G, Garbe C, et al. Overall survival in patients with BRAF-mutant melanoma receiving encorafenib plus binimetinib versus vemurafenib or encorafenib (COLUMBUS): a multicentre, open-label, randomised, phase 3 trial. Lancet Oncol 2018; 19: 1315-27. (Among 577 patients with advanced or metastatic melanoma and BRAF V600 mutations in a randomized controlled trial [Dummer 2018 above], treatment with the combination of encorafenib and binimetinib led to prolonged overall survival compared to vermurafenib alone but not to encorafenib alone, while tolerability was greatest with the combination although ALT elevations arose in 11% vs 6% and 8% of subjects, which were above 5 times ULN in 5% on the combination vs 1-2% on monotherapy). 30219628
Martin-Liberal J. Encorafenib plus binimetinib: an embarrassment of riches. Lancet Oncol 2018; 19: 1263-4. (Editorial in response to Dummer [2018] and Dummer [2018]). 30219625
Shirley M. Encorafenib and binimetinib: first global approvals. Drugs 2018; 78: 1277-84. (Review of the history, mechanism of action, pharmacology, clinical efficacy and safety of the combination of encorafenib and binimetinib as therapy of malignant melanoma; mentions that the two agents target different kinases in the RAS/RAF/MEK/ERK signaling pathway and that together they are better tolerated than kinase inhibitor monotherapies, although ALT elevations above 5 times ULN occur in 6% of patients). 30117021

## OTHER REFERENCE LINKS

1. Recent References on Encorafenib and Binimetinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Encorafenib+Binimetinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Encorafenib and Binimetinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Encorafenib+Binimetinib)